# Olutasidenib

## OVERVIEW

### Introduction

Olutasidenib is a small molecule inhibitor of mutated isocitrate dehydrogenase-1 (IDH1) that is used in the treatment of adults with relapsed or refractory acute myelogenous leukemia with mutated IDH1. Olutasidenib is associated with a high rate of serum aminotransferase elevations during therapy that can be severe and require early discontinuation and occasionally have led to clinically apparent acute liver injury.

### Background

Olutasidenib (oh loo” ta sid’ e nib) is an orally available, small molecule inhibitor of mutated isocitrate dehydrogenase-1 (IDH1) and is used to treat relapsed or refractory cases of acute myelogenous leukemia (AML) that harbor specific mutations in IDH1. Isocitrate dehydrogenase is an oxidative decarboxylase which is important in maintaining normal progenitor and stem cell differentiation. Mutation in IDH1 can lead to accumulation of a toxic intermediate (2-hydroxyglutarate; 2-HG) that blocks normal cell differentiation and promotes cancer cell growth. IDH1 mutations are found in 7% to 14% of patients with AML and in 3% to 4% with myelodysplastic syndromes. In cell culture, olutasidenib has been found to decrease 2-HG levels and restore normal cell differentiation in cancer cells with IDH1 mutations. Clinical trials of olutasidenib have demonstrated beneficial objective response rates in adult patients with AML and IDH1 mutations. Olutasidenib was approved in the United States in 2022 for adults with relapsed or refractory AML and a susceptible IDH1 mutation. Olutasidenib is available in capsules of 150 mg under the brand name Rezlidhia. The recommended dose is 150 mg twice daily until disease progression or unacceptable toxicity. Common side effects of olutasidenib include symptoms of fatigue, arthralgia, constipation, diarrhea, nausea, dyspnea, fever, rash, cough, and mucositis. Therapy is also associated with increases in serum aminotransferase levels, alkaline phosphatase, bilirubin, uric acid, and creatinine as well as deceases in serum potassium and sodium. Thrombocytopenia, neutropenia and anemia are common during olutasidenib therapy, but are most likely due to the underlying acute leukemia. Less common but potentially severe adverse events include differentiation syndrome and hepatotoxicity.

### Hepatotoxicity

In the published preregistration clinical trials of olutasidenib, rates of serum ALT or AST elevations were 46% and 47% which were above 5 times the upper limit of normal (ULN) in 13% and 10%, resulting in dose modification in at least 10% of patients and discontinuation ultimately in 5% of patients. One individual treated with the combination of azacytidine and olutasidenib died of hepatic failure, and another developed a clinically apparent but self-limited episode of cholestatic hepatitis. Most hepatic effects occurred early during therapy, usually during the first or second month, but isolated instances arose as late as 5 months after starting olutasidenib. Since its approval and general availability, at least one other case of acute hepatitis with jaundice has been reported from clinical trials of olutasidenib.

In prelicensure studies, olutasidenib therapy was also associated with “differentiation syndrome” in 9% to 16% of patients that was sometimes severe and occasionally fatal. Differentiation syndrome is the result of the sudden and rapid proliferation of myeloid cells results in release of inflammatory cytokines and symptoms of respiratory distress, accompanied by hypoxia, pulmonary infiltrates, and pleural effusions. Other manifestations include fever, renal impairment, lymphadenopathy, bone pain, peripheral edema, and weight gain. Liver dysfunction can also occur but is usually overshadowed by the more severe systemic manifestations. The onset of differentiation syndrome is generally within 2 to 8 weeks of starting therapy, and the course can be severe. Management includes prompt discontinuation of therapy and use of corticosteroids in more severe cases. Patients can be restarted on olutasidenib once the syndrome resolves. Olutasidenib has a black box warning of differentiation syndrome with specific recommendations for its prompt recognition and management. The label also warns about the risk of hepatotoxicity with recommendation to monitor liver tests during treatment and interrupt and reduce or discontinue if hepatotoxicity occurs.

Likelihood score: D (possible but uncommon cause of clinically apparent liver injury).

### Mechanism of Injury

Olutasidenib therapy has been clearly linked to serum enzyme elevations and to uncommon instances of clinically apparent liver injury. It is metabolized in the liver largely by CYP 3A and liver injury may be due to its metabolism to an immunogenic or toxic intermediate. Some cases may be due to differentiation syndrome, a well-known complication of olutasidenib therapy in which there is a release of proinflammatory cytokines that may cause serum aminotransferase elevations. Olutasidenib is also susceptible to drug-drug interactions with inducers or inhibitors of CYP 3A4.

### Outcome and Management

Olutasidenib has been clearly linked to serum aminotransferase elevations and clinically significant liver injury. For this reason, frequent monitoring of liver tests is recommended in the product label with testing at baseline, at least once weekly for the first two months, once every other week for the third month, once during the fourth month, and every other month thereafter for the duration of therapy. Serum aminotransferase elevations above 5 times ULN should lead to dose reduction or temporary cessation. ALT or AST elevations above 20 times ULN or any elevations accompanied by jaundice or symptoms should lead to discontinuation. There does not appear to be cross reactivity in risk for hepatic injury among the various IDH inhibitors but few instances have been studied.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other IDH1 and IDH2 Inhibitors: Enasidenib, Ivosidenib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Olutasidenib – Rezlidhia®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Olutasidenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Olutasidenib | 1887014-12-1 | C18-H15-Cl-N4-O2 | SID: 376005569

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2024

Abbreviations: AML, acute myelogenous leukemia; IDH1, isocitrate dehydrogenase-1.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of small molecule enzyme inhibitors such as olutasidenib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase enzyme inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not the isocitrate dehydrogenase inhibitors such as olutasidenib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/215814Orig1s000MultidisciplineR.pdf (Integrated FDA review of the data on safety and efficacy of olutasidenib that formed the basis of its approval as therapy of adult with relapsed or refractory acute myelogenous leukemia, mentions that ALT elevations arose in 46% of patients, were above 5 times ULN in 11%, and that among 425 patients treated in two studies of olutasidenib, there were 19 cases of suspected drug induced liver injury, two of which were considered convincingly related to the drug, one of which was fatal).
Watts JM, Baer MR, Yang J, Prebet T, Lee S, Schiller GJ, Dinner SN, et al. Olutasidenib alone or with azacitidine in IDH1-mutated acute myeloid leukaemia and myelodysplastic syndrome: phase 1 results of a phase 1/2 trial. Lancet Haematol. 2023;10:e46-e58. (Among 78 patients with AML or a myelodysplastic syndrome who were treated with olutasidenib with or without azacytidine, the objective response rate varied by indication and drug regimen from 25% to 77%, and adverse events were largely thrombocytopenia, febrile neutropenia and anemia; liver test abnormalities above 5 times the ULN arose in 10 patients [13%], led to discontinuation in 2 [3%], but ultimately resolved in all). 36370742
de la Fuente MI, Colman H, Rosenthal M, Van Tine BA, Levacic D, Walbert T, Gan HK, et al. Olutasidenib (FT-2102) in patients with relapsed or refractory IDH1-mutant glioma: A multicenter, open-label, phase Ib/II trial. Neuro Oncol. 2023;25:146-156. (Among 26 patients with relapsed or refractory brain gliomas harboring IDH1 mutations treated with olutasidenib [150 mg twice daily], only 2 had an objective response, but all [100%] had adverse events that included ALT elevations in 8 [31%] of which 3 [12%] were above 5 times ULN, and one of which resulted in a symptomatic and icteric acute hepatitis). 35639513
Kang C. Olutasidenib: first approval. Drugs. 2023;83:341-346. (Summary of the mechanism of action, history of development, pharmacokinetics, efficacy, and safety of olutasidenib shortly after its approval in the US, mentions that ALT elevations arose is 23-31% of patients). 36848032
Olutasidenib (Rezlidhia) for acute myeloid leukemia. Med Lett Drugs Ther. 2023;65:e58-e59. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of olutasidenib shortly after its approval for use in AML in the US, mentions that hepatotoxicity can occur and that routine monitoring of liver function tests is recommended before starting and regularly for the duration of treatment). 37020343

## OTHER REFERENCE LINKS

Recent References on Olutasidenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Olutasidenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Olutasidenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Olutasidenib)